# Cocaine

## OVERVIEW

### Introduction

Cocaine is a benzoid acid ester that that was originally used as a local anesthetic, but is no longer used because of its potent addictive qualities. When given in high doses systemically, cocaine has mood elevating effects that have led to its widescale abuse. High doses of cocaine can be associated with toxic reactions including hyperthermia, rhabdomyolysis, shock and acute liver injury which can be severe and even fatal.

### Background

Cocaine (koe kane') is a potent local anesthetic that appears to act by inhibition of voltage-gated sodium channels, increasing the threshold for electric excitability of nerve axons and thus decreasing neuroconduction. In the central nervous system, cocaine appears to block both norepinephrine and serotonin reuptake. High doses produce euphoria followed by withdrawal symptoms, leading to a repeated desire to restart it and great abuse potential. Chronic use is associated with irritability, paranoia, violence and drug seeking behavior. Cocaine is one of the most addictive medications known. For this reason, cocaine is listed as a Schedule I drug, indicating that it has high abuse potential and no current medical usefulness. Cocaine abuse is relatively common; an estimated 600,000 Americans regularly abuse cocaine.

### Hepatotoxicity

Cocaine has many serious medical consequences including cardiac arrhythmias, coronary artery spasm and myocardial infarction, cerebrovascular accidents, subarachnoid hemorrhage, seizures, hallucinations, intestinal ischemia, renal infarction, rhabdomyolysis and acute liver injury. Cocaine is a not infrequent cause of sudden “unexplained” death in young adults. Hepatotoxicity usually arises hours to a few days after an acute overdose, generally following or accompanying other major organ involvement. The clinical phenotype of cocaine hepatototoxicity is usually acute hepatic necrosis. Initially, serum aminotransferase and LDH levels are markedly elevated with minimal increase in alkaline phosphatase. The prothrombin time becomes abnormal rapidly and may also reflect disseminated intravascular coagulation (DIC). The serum bilirubin begins to rise after 2 to 3 days. Immunoallergic features and autoantibodies are usually absent. Liver histology usually shows centrolobular (zone 3) necrosis and fatty change, features that resemble ischemic hepatitis or liver injury due to hyperthermia, factors that may partially mediate the hepatotoxic effects of cocaine. In self-limited cases, recovery is rapid and serum aminotransferase levels usually return to normal within 1 to 2 weeks.

Likelihood score: A[HD] (well known cause of acute liver injury, but only when taken as an overdose).

### Mechanism of Injury

Cocaine is believed to cause liver injury by conversion to a toxic metabolite as a result of P450 metabolism. In experimental animal models, modulation of P450 activity by inducers, inhibitors or alcohol changes the relative toxicity and pattern of injury from cocaine. In humans, it is less clear whether the hepatic injury is mediated by a toxic metabolite of cocaine as opposed to the direct effects of hyperthermia, anoxia or hepatic ischemia.

### Outcome and Management

The liver injury due to the cocaine is usually self-limited and resolves rapidity. However, fatal instances have been reported often due to the other major systemic effects of cocaine overdose (myocardial infarction, stroke, multiorgan failure). There is no specific therapy or antidote for acute cocaine toxicity. Infusions of N-acetylcysteine are often given because of the similarity of the injury to acetaminophen hepatotoxicity.

Drug Class: CNS Stimulants, Agents of Abuse

Other CNS Stimulants: Amphetamines, Armodafinil, Atomoxetine, Methylphenidate, Modafinil

## CASE REPORT

### Case 1. Acute hepatic necrosis and rhabdomyolysis after cocaine use.

[Modified from: Kanel GC, Cassidy W, Shuster L, Reynolds TB. Cocaine-induced liver cell injury: comparison of morphological features in man and in experimental models. Hepatology 1990; 11: 646-51. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/2328957)]

A 24 year old man with bizarre behavior after cocaine use was admitted for observation in a jail ward with tachycardia (100/min), fever (100 oF) and tachypnea (30/min). Examination showed small pupils, but was otherwise normal. He had a history of snorting and “free-basing” cocaine and a previous history of injection drug use. Laboratory results showed elevations in CPK, ALT and AST. He was given intravenous hydration, but developed progressive renal failure and was started on dialysis. His liver tests progressively worsened (Table). After three days he became confused, hypoglycemic, and had signs of progressive hepatic failure. The following day he developed respiratory failure followed by hypotension and cardiac arrest not responding to resuscitative measures. On autopsy, the liver showed midzonal and central (zones 2 and 3) coagulative necrosis, with prominent fatty change in surviving periportal hepatocytes and minimal inflammatory change with no cholestasis, fibrosis or bile duct injury.

#### Key Points

Medication: | Cocaine (unknown amount)
Pattern: | Hepatocellular (R=40)
Severity: | 5+ (fatal)
Latency: | 1 day
Recovery: | None
Other medications: | None

#### Laboratory Values

Time After Stopping | ALT (U/L) | CPK (U/L) | Alk P (U/L) | Protime* | Bilirubin (mg/dL) | Other
| Arrest for bizarre and combative behavior after cocaine use
0 | 135 | 617
1 day | 1760 | 14,240 | 146 | 12% | 1.9
2 days | >10,000 | 46,480 | | 15% | 3.5 | Renal failure
4 days | 2,280 | 28,860 | 194 | 9% | 8.7 | Hypoglycemia
| Death from cardio-respiratory arrest
Normal | <42 | <170 | <90 | >85% | <1.2

* Prothrombin activity as a precent of normal.

#### Comment

Cocaine is one of the most addictive and dangerous drugs of abuse. This case demonstrates the range of its medical complications, including initial bizarre and combative behavior followed by rhabdomyolysis, hepatic and renal failure, respiratory arrest and cardiovascular collapse. The pattern of liver injury was acute hepatic necrosis with rapid rise and fall of serum aminotransferase levels, little change in alkaline phosphatase and delayed rise in serum bilirubin. Typically, the prothrombin time becomes abnormal early and signs of hepatic encephalopathy can arise at the time that serum bilirubin levels are minimally elevated. Rhabdomyolysis and renal failure are also frequent and the cause of death is usually multiorgan failure rather than acute liver failure per se. Liver histology resembles that of acute ischemic hepatitis and acetaminophen poisoning.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cocaine – No Commercial Products

DRUG CLASS

Central Nervous System Stimulants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dextroamphetamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cocaine | 50-36-2 | C17-H21-N-O4 | 2D chemical structure of 50-36-2

## ANNOTATED BIBLIOGRAPHY

References updated: 26 October 2017

Zimmerman HJ. Cocaine. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 712-4. (Expert review of hepatotoxicity published in 1999 mentions that cocaine is known to cause hepatic injury, although this is often eclipsed by cardiac, neurological or muscular damage; it is a dose dependent hepatotoxin in experimental animals).
Larrey D, Ripault MP. Illegal and recreational compounds. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 456-7. (Review of hepatotoxicity of drugs of abuse mentions that cocaine can cause a severe hepatitis, usually arising within 2 days and associated with marked aminotransferase elevations and other organ failure).
O’Brien CP. Drug addiction. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 649-59. (Textbook of pharmacology and therapeutics).
Ehrlich P. [Studies on the effects of cocaine]. Dtsh Med Wochenschr 1890; 16: 716. Not indexed in PubMed. (Early report on effects of cocaine, largely as an anesthetic).
Marks V, Chapple PA. Hepatic dysfunction in heroin and cocaine users. Br J Addict Alcohol Other Drugs 1967; 62: 189-95. (Among 89 heroin and cocaine users, 6 were jaundiced and 69% had ALT elevations and marked elevations occurred with relapse in cocaine and heroin use). 5231851
Rubel LR, Ishak KG. The liver in fatal exertional heatstroke. Liver 1983; 3: 249-60. (Liver histology of 50 cases of fatal heatstroke arising during military training in 17-36 year olds; initially fatty change, vacuolization and congestion, followed by zone 3 coagulative necrosis, cholestasis and microvacuolar fatty change). 6672506
Kloss MW, Rosen GM, Rauckman EJ. Cocaine-mediated hepatotoxicity. A critical review. Biochem Pharmacol 1984; 33: 169-73. (Discussion of the mechanism of hepatic injury by cocaine in animal model systems). 6367747
Armen R, Kanel GC, Reynolds T. Phencyclidine-induced malignant hyperthermia causing submassive liver necrosis. Am J Med 1984; 7: 167-72. (3 patients developed agitation, combative behavior and hyperthermia [107-108 oF] shortly after phencyclidine abuse with rise in CPK, ALT and bilirubin [peak levels 15.7-22.5 mg/dL] by day 2; one patient died and 2 recovered with rapid fall of enzymes to normal, liver histology on autopsy showing centrolobular necrosis suggestive of hyperthermia injury). 6741977
Cregler LL, Mark H. Medical complications of cocaine abuse. N Engl J Med 1986; 315: 1495-500. (Review of the severe medical complications of cocaine abuse including coronary artery spasm, myocardial infarction, rupture of aorta, subarachnoid bleed, stroke, seizures, intestinal and renal infarction; hepatotoxicity not discussed). 3537786
Bates CK. Medical risks of cocaine use. West J Med 1988; 148: 440-4. (Clinical description of cocaine reactions; early, mild effects are behavioral changes and teeth grinding with tachycardia, hypertension and hyperthermia; more severe reactions are then followed by excited delirium, stupor, ventricular arrhythmias and sudden death usually from myocardial infarction or respiratory arrest). 3291396
Perino LE, Warren GH, Levine JS. Cocaine-induced hepatotoxicity in humans. Gastroenterology 1987; 93: 176-80. (32 year old man developed bizarre behavior and respiratory arrest after snorting cocaine, with AST rising from 620 to 10,700 U/L and bilirubin 0.3 to 4.5 mg/dL and with progressive bradycardia and cardiac arrest within 2 days of admission; autopsy showed mild fatty change and periportal and midzonal necrosis). 3582904
Porter JM, Sussman MS, Rosen GM. Cocaine-induced hepatotoxicity. Hepatology 1988; 8: 1713. (Commentary on Perino et al [1987]). 3192186
Roth D, Alarcón FJ, Fernandez JA, Preston RA, Bourgoignie JJ. Acute rhabdomyolysis associated with cocaine intoxication. N Engl J Med 1988; 319: 673-7. (39 patients with acute rhabdomyolysis after cocaine use; 35 were agitated or combative, 4 comatose; CPK levels >10 times ULN in all, muscle tenderness in 20, hyperthermia in 13, acute renal failure in 13, 8 requiring dialysis, disseminated intravascular coagulation in 7, severe liver dysfunction in 13 [ALT mean 5558 U/L, AST 4415 U/L, direct bilirubin 8.7 mg/dL]; 2 died of cardiac arrhythmias and 4 of multiorgan failure). 3412385
Campbell BG. Cocaine abuse with hyperthermia, seizures and fatal complications. Med J Aust 1988; 149: 387-9. (23 year old woman developed agitation and seizures shortly after cocaine use with fever to 42 ^o^C and subsequent disseminated intravascular coagulation, rhabdomyolysis, acute renal failure, and jaundice [bilirubin initially normal rising to 2.6 mg/dL, AST 99 to 3415 U/L, CK 152 to 10,000 U/L], dying 45 hours after admission). 3173196
Jandreski MA, Bermes EW, Leischner R, Kahn SE. Rhabdomyolysis in a case of free-base cocaine ("crack") overdose. Clin Chem 1989; 35: 1547-9. (27 year old man developed bizarre behavior followed by combativeness after smoking crack cocaine, with CPK 30 times ULN, ALT and AST >40 times ULN the following day and rise in creatinine, but spontaneous recovery and resolution within one week). 2758612
Bauwens JE, Boggs JM, Hartwell PS. Fatal hyperthermia associated with cocaine use. West J Med 1989; 150; 210-2. (2 men, aged 30 and 38 years old, developed seizures and agitation after cocaine use with temperature of 41.1 and 43 ^o^C with rapid appearance of rhabdomyolysis, renal failure, disseminated intravascular coagulation, liver failure within 1 day and death at 7 days). 2728444
Kanel GC, Cassidy W, Shuster L, Reynolds TB. Cocaine-induced liver cell injury: comparison of morphological features in man and in experimental models. Hepatology 1990; 11: 646-51. (24 year old man developed bizarre behavior after cocaine use with rhabdomyolysis and subsequent jaundice [bilirubin rising from 1.9 to 8.7 mg/dL, ALT 135 to >10,000 U/L, CPK 617 to 46,480], renal failure, seizures, multiorgan failure and death; autopsy showed zone 2 and 3 hepatic necrosis, periportal fat and minimal inflammation: Case 1). 2328957
Wanless IR, Dore S, Gopinath N, Tan J, Cameron R, Heathcote EJ, Blendis LM, et al. Histopathology of cocaine hepatotoxicity. Report of four patients. Gastroenterology 1990; 98: 497-501. (Liver histology in 3 women and 1 man with cocaine hepatotoxicity including one fatality; ages 24-28 years, 2 presenting acutely with bizarre behavior followed by rhabdomyolysis and renal and liver failure [bilirubin 3.7 and 4.9 mg/dL, ALT 7300 and 10,200 U/L, Alk P 71 and 123 U/L], one dying on day 6 and one recovering by day 12; two patients had a more subacute presentation several days after exposure [bilirubin normal, ALT 1940 and 435, CPK 6720 and 27,000 U/L], resolving in 7-10 days; histology showed variable amounts of zone 3 coagulative necrosis sometimes extending to zone 2 with fat in remaining hepatocytes, minimal inflammation). 2153087
Gubbins GP, Schiffman RM, Alapati RS, Batra SK. Cocaine-induced hepatonephrotoxicity: a case report. Henry Ford Hosp Med J 1990; 38: 55-6. (35 year old woman developed dark urine 2 days after smoking crack cocaine [bilirubin 3.0 mg/dL, ALT 9295 U/L, Alk P 131 U/L, CPK 258 U/L, creatinine 5.3 mg/dL], resolving over next two weeks). 2228713
Tabasco-Minguillan J, Novick DM, Kreek MJ. Liver function tests in non-parenteral cocaine users. Drug Alcohol Depend 1990; 26: 169-74. (56 users of cocaine, but not injection drugs, only 3 had elevated ALT levels [peak 111 U/L] and two of them had hepatitis B suggesting that cocaine use, by itself, does not cause chronic hepatitis or persistent ALT elevations). 2242718
Silva MO, Roth D, Reddy KR, Fernandez JA, Albores-Saavedra J, Schiff ER. Hepatic dysfunction accompanying acute cocaine intoxication. J Hepatol 1991; 12: 312-5. (Retrospective analysis of 39 patients with cocaine intoxication and rhabdomyolysis; 23 had ALT elevations, 16 were severe; liver injury occurred in all 13 patients with renal failure and in 7 of 8 who died; autopsy showed centrolobular necrosis, compatible with shock or hyperthermia). 1940259
Mallat A, Dhumeaux D. Cocaine and the liver. J Hepatol 1991; 12: 275-8. (Editorial accompanying article by Silva [1991]). 1940255
Saltzman JR, Johnston DE. Sickle cell crisis and cocaine hepatotoxicity. Am J Gastroenterol. 1992; 87: 1661-4. (33 year old man with sickle cell anemia and multiple crises, presented with rise in bilirubin [6.2 at baseline to 37.5 mg/dL], ALT [24 to 726 U/L] and Alk P [152 to 370 U/L] after cocaine use; also taking amoxicillin/clavulanate). 1442696
Peyrière H, Mauboussin JM. Cocaine-induced acute cytologic hepatitis in HIV-infected patients with nonactive viral hepatitis. Ann Intern Med 2000; 132: 1010-1. (3 patients with HIV/HBV or HCV coinfection who had rises in ALT levels [baseline of 7-30 rising to 340-1669 U/L], without jaundice or rise in Alk P a few days after intranasal cocaine use ). 10858171
Campos Franco J, Martínez Rey C, Pérez Becerra E, González Quintela A. [Cocaine related fulminant liver failure]. An Med Interna 2002; 19: 365-7. (23 year old woman presented with confusion 10 hours after cocaine use [bilirubin 1.2 mg/dL, ALT 1031 U/L, Alk P 103 U/L], worsening for 6 days and then resolving rapidly over next 10 days; biopsy showed centrolobular coagulative necrosis with minimal inflammation). 12224146
Hurtova M, Duclos-Vallée JC, Saliba F, Emile JF, Bemelmans M, Castaing D, Samuel D. Liver transplantation for fulminant hepatic failure due to cocaine intoxication in an alcoholic hepatitis C virus-infected patient. Transplantation 2002; 73: 157-8. (33 year old man with chronic hepatitis C presented with acute liver failure shortly after iv cocaine use [ALT 30 times ULN, CPK 27,000 U/L, prothrombin index 9%], undergoing liver transplantation; explant showing centrolobular coagulative necrosis and marked steatosis). 11792999
Kramer L, Bauer E, Schenk P, Steininger R, Vigl M, Mallek R. Successful treatment of refractory cerebral oedema in ecstasy/cocaine-induced fulminant hepatic failure using a new high-efficacy liver detoxification device (FPSA-Prometheus). Wien Klin Wochenschr 2003; 115: 599-603. (27 year old man developed coma within hours of injecting heroin and cocaine and taking 300 mg of MDMA with evidence of multiorgan failure and rhabdomyolysis [bilirubin 1.1 rising to 9.5 mg/dL, ALT 5870 U/L, LDH 11,030 U/L, INR 1.6 rising to 3.2] and was treated with a fractionated plasma separation and adsorption device, with ultimate resolution within 3 weeks). 14531175
Balaguer F, Fernández J, Lozano M, Miquel R, Mas A. Cocaine-induced acute hepatitis and thrombotic microangiopathy. JAMA 2005; 293: 797-8. (22 year old woman developed jaundice a few days after cocaine use [bilirubin 12.0 rising to 71.4 mg/dL, ALT 1305 U/L, Alk P 308 U/L], with respiratory and renal failure and hemolytic anemia but eventual resolution). 15713768
Abd El-Rahman AM, Ammar H. Cocaine-induced acute hepatitis and thrombotic microangiopathy. JAMA 2005; 293: 2715; author reply 2715-6. (Letter in response to Balaguer [2005] discussing use of fresh frozen plasma exchange rather than albumin). 15941798
Jiménez Pérez M, Marín García D, Santaella Leiva I, Olmedo García R. [Cocaine-induced hepatotoxicity]. Med Clin (Barc) 2008; 130: 279. Spanish. (42 year old man became semicomatose 10 hours after inhaling cocaine [bilirubin 1.9 mg/dL, ALT 2673 U/L, GGT 244 U/L, creatinine 5 mg/dL], with rhabdomyolysis and renal failure requiring dialysis, but ultimate recovery and near normal liver enzymes 8 days after admission). 18355433
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/18955056) (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 3 cases were attributed to atomoxetine and one to methylphenidate, but none to cocaine or ecstasy).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/20949552) (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including one attributed to cocaine and one to ecstasy).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, Presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to cocaine or amphetamine use). 23419359
Giuliani E, Albertini G, Vaccari C, Manenti A, Barbieri A. Multi-organ failure following severe cocaine-tetramisole intoxication in a body-packer. Anaesth Intensive Care. 2012; 40: 562-4. (51 year old woman, who had swallowed sealed packets of cocaine to smuggle them into Italy, had sudden onset of seizures followed by coma and cardiac arrest; after resuscitation, ALT levels rose starting on day 2 to a peak of 6000 U/L on day 4 and rapid recovery and discharge on day 7). 22577932
Zimmerman JL. Cocaine intoxication. Crit Care Clin 2012; 28: 517-26. (Review of the major complications of cocaine overdose including cardiac, neurologic, respiratory and renal; no discussion of hepatotoxicity). 22998988
Trabulo D, Marques S, Pedroso E. Cocaine capsules in the colon: the internal concealment of illicit drugs. J Gastrointestin Liver Dis 2015; 24: 9. (26 year old man was arrested and jailed for drug smuggling and developed fever and abdominal pain 2 days later, X-rays showing "nodules" in colon which were successfully removed by enemas; no follow up provided). 25822426
Guollo F, Narciso-Schiavon JL, Barotto AM, Zannin M, Schiavon LL. Significance of alanine aminotransferase levels in patients admitted for cocaine intoxication. J Clin Gastroenterol 2015; 49: 250-5. (Retrospective analysis of 93 patients wtih cocaine intoxication, 5 of whom had marked ALT elevations [>20 times ULN], all were critically ill and had rhabdomyolysis, two had renal failure and one died). 24518798
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to cocaine or other illicit drugs). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Cocaine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=cocaine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cocaine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=cocaine)